# Gentamicin

## OVERVIEW

### Introduction

Gentamicin is a parenterally administered, broad spectrum aminoglycoside antibiotic typically used for moderate to severe gram negative infections. Despite its wide use, gentamicin has not been definitively linked to instances of clinically apparent liver injury.

### Background

Gentamicin (jen" ta mye' sin) is a aminoglycoside with broad bacteriocidal activity against many aerobic gram negative and some aerobic gram positive organisms. Gentamicin is the most commonly used aminoglycoside antibiotic and is indicated for moderate-to-severe bacterial infections caused by sensitive agents, primarily gram negative bacteria. Like other aminoglycosides, gentamicin is thought to act by binding to bacterial ribosomes and inhibiting protein synthesis. Nevertheless, gentamicin is considered bacteriocidal as well as bacteriostatic. Gentamicin and other aminoglycosides are typically used in combination with a penicillin or cephalosporin for treatment of severe infections with E. coli, Staphylococcus aureus, Enterobacter, Klebsiella, Serratia, Pseudomonas aeruginosa, and other gram negative bacteria resistant to less toxic antibiotics. Gentamicin is most commonly used for septicemia, bacterial endocarditis, peritonitis, meningitis, pelvic inflammatory disease and pneumonia. Gentamicin was first approved for use in the United States in 1970 and remains in wide use. Gentamicin is available in multiple generic parenteral formulations and the typical adult dose is 3 to 5 mg/kg per day im or iv, usually in three divided doses and often after a loading dose. Doses must be modified based upon renal function and monitoring of drug levels is advisable. Topical formulations are also available for local wound, tissue and ophthalmologic anti-bacterial therapy. Common side effects of gentamicin include dizziness, headache, confusion, nausea and skin rash. Important, dose related adverse effects include oto- and nephrotoxicity, which are shared by all aminoglycosides.

### Hepatotoxicity

Intravenous and intramuscular therapy with gentamicin has been linked to mild and asymptomatic elevations in serum alkaline phosphatase levels, but rarely affects aminotransferase levels or bilirubin, and changes resolve rapidly once gentamicin is stopped. Only isolated case reports of acute liver injury with jaundice have been associated with aminoglycoside therapy including gentamicin, most of which are not very convincing. The hepatic injury described in these reports is typically mixed but can evolve into a cholestatic hepatitis. The latency to onset is rapid, occurring within 1 to 3 weeks and is typically associated with skin rash, fever and sometimes eosinophilia. Recovery typically occurs within 1 to 2 months and chronic injury has not been described. Aminoglycosides are not listed or mentioned in large case series of drug induced liver disease and acute liver failure; thus, hepatic injury due to gentamicin is rare if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of symptomatic, icteric hepatic injury from gentamicin is not known, but likely to be immunoallergic. Uptake of aminoglycosides into hepatocytes is limited and they are rapidly excreted in the urine; high concentrations are found in mainly in renal tubular cells and hair cells of inner ear perhaps explaining why they are more likely to cause nephro- or oto- rather than hepatotoxicity.

### Outcome and Management

The outcome of hepatic injury due to aminoglycosides is usually benign. Acute liver failure has not been associated with gentamicin use and no convincing cases of chronic bile duct vanishing syndrome have been described after its use. Patients with clinical apparent reactions to gentamicin should probably avoid all systemic aminoglycoside use.

References to the safety and potential hepatotoxicity of gentamicin are provided in the Overview section on the Aminoglycosides.

Drug Class: Aminoglycosides

Other Drugs in the Class: Amikacin, Neomycin, Plazomicin, Streptomycin, Tobramycin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Gentamicin – Generic

DRUG CLASS

Aminoglycosides

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Gentamicin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Gentamicin | 1405-41-0 | H2-O4-S.x-Unspecified | Gentamicin chemical structure

## OTHER REFERENCE LINKS

1. Recent References on Gentamicin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=gentamicin/AE+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Gentamicin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=gentamicin)